# Antimalarial Agents

## OVERVIEW

Malaria is one of the world’s most common and important infectious diseases, affecting 200 to 300 million persons and accounting for half a million deaths yearly, mostly children. Malaria in humans is caused by four Plasmodium species, P. falciparum, vivax, ovale and malariae and is spread by the bite of the female Anopheles mosquito. The majority of infections and deaths due to malaria occur in Africa and Asia. Between 1000 and 1500 cases are reported in the United States each year, virtually all being related to travel to endemic areas, and deaths being very rare and usually associated with misdiagnosis, inadequate therapy or lack of compliance.

The major drugs used to treat malaria include amodiaquine (Camoquin, Flavoquine), artemisinin derivatives (artesunate: Adamsunate; artemether-lumefantrine, Coartem), atovaquone/proguanil (Malarone), chloroquine (Aralen), mefloquine (Lariam), mepacrine or quinacrine (Atabrine), primaquine (generic only), sulfadoxine/pyrimethamine (Fansidar), and quinine (Qualaquin). Not all of these agents are available in the United States, but the majority of therapy of malaria is administered in Africa and Asia where these agents and others are available.

Quinine was the initial drug used for prophylaxis and therapy of malaria, being the active component of Cinchona bark that was used for centuries in South America for chills and fever, and that was introduced into Western medicine by Jesuit priests returning from Peru in the 17th Century. Quinine is active against malaria, but has been replaced by synthetic aminoquinolone derivatives such as chloroquine that are more potent and better tolerated. Quinine is still used rarely for therapy of chloroquine-resistant P. falciparum malaria. Quinine can cause an acute allergic response with fever, nausea, abdominal pain and liver injury, but it is rarely severe.

Chloroquine has been the standard antimalarial drug since its development during World War II and is used both for therapy and prophylaxis. Chloroquine resistance has become a growing problem, particularly for P. falciparum infections. Chloroquine rarely causes hepatic injury, although it can cause an acute exacerbation of porphyria cutanea tarda with hepatic involvement.

Amodiaquine is an aminoquinolone structurally related to chloroquine which has some advantages, but which can cause severe hepatitis and agranulocytosis which led to its abandonment as prophylaxis. It is still used in combination with other agents for therapy of chloroquine-resistant P. falciparum.

Mefloquine is an aminoquinoline similar to quinine which is used both for prophylaxis and treatment of malaria, it being effective against many chloroquine-resistant P. falciparum infections. Mefloquine resistance has become a growing problem with it use as monotherapy. Mefloquine has only rarely been linked to hepatic injury, but it has frequent neuro-psychiatric side effects which has led to limitations on its use.

Mepacrine is an acridine dye that was developed in the 1920s and found to have activity against P. vivax and falciparum infection. It was extensively used by the U.S. military in the South Pacific during World War II when it was known as atabrine. It was largely replaced by chloroquine thereafter, but found new uses in the treatment of other parasitic diseases and as an antiinflammatory agent in the therapy of lupus erythematosus. Mepacrine is commonly referred to as quinacrine in the United States, but it currently is not approved for any use, although available in some countries abroad or via the internet.

Primaquine is an aminoquinolone that has been used for many decades as prophylaxis and therapy of malaria. It shares cross resistance with chloroquine. Primaquine has not been linked to cases of clinically apparent liver injury.

The combination of atovaquone with proguanil is used for prevention and therapy of chloroquine-resistant P. falciparum infection. This combination has been linked to transient serum enzyme elevations and to rare instances of clinically apparent liver injury.

The combination of pyrimethamine and sulfadoxine (referred to as Fansidar) is also no longer used for prophylaxis against malaria because of hepatotoxicity and severe allergic reactions, but it is still used in combination with other agents in the treatment of P. falciparum malaria.

Artemisinin is an ancient Chinese herbal medication used for malarial fevers and recently shown to have excellent potency with a distinctive mode of action and little cross-resistance with the aminoquinolones. Artemisinin derivatives have been developed for oral and parenteral use and introduced throughout the world in combination with other agents for therapy of malaria. These derivatives include artesumate, artemisinin, dihydroartemisinin, artemether and arteether, many of which have been linked to instances of idiosyncratic liver injury. The combination of artemether with lumefantrine is available as therapy of P. falciparum malaria in the United States.

The description of the hepatotoxicity of the antimalarial agents includes some information on dose regimens, but these short descriptions should not be used to guide therapy. Specific recommendations on the therapy of malaria with details on diagnosis, management, drug dosage and safety are available at the Centers for Disease Control and Prevention (CDC) website: http://www.cdc.gov/MALARIA/.

The different antimalarial agents are discussed separately with appropriate references. All relevant references to hepatotoxicity of the antimalarials are also given below.

The following links are to individual drug records.

- Artemisinin
- Amodiaquine
- Atovaquone
- Chloroquine
- Mefloquine
- Mepacrine
- Primaquine
- Proguanil
- Quinine
- Sulfadoxine-Pyrimethamine
- Tafenoquine

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2017

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; amodiaquine has been associated with many cases of severe hepatitis, some fatal; chloroquine has little hepatotoxic effect; mefloquine can lead to elevated ALT levels; primaquine has not been linked to hepatic injury in humans; quinine is an ancient drug that causes granulomatous hepatitis rarely; pyrimethamine/sulfadoxine can cause acute hepatic injury which is usually attributed to the sulfonamide component; the book predated the availability of atovaquone/proguanil and the artemisinin derivatives).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Livingood CS, Dieuaide FR. Untoward reactions attributable to atabrine. JAMA 1945; 129: 1091. Not in PubMed (Describes several forms of eczematoid dermatitis in soldiers taking atabrine as prophylaxis against malaria in the Pacific theater; rare cases had accompanying severe hepatitis that can be fatal).
Linden IH, Steffen CG, Newcomer VD, Chapman M. Development of porphyria during chloroquine therapy for chronic discoid lupus erythematosus. Calif Med 1954; 81: 235-7. (48 year old man with discoid lupus developed acute porphyria 3 days after starting chloroquine with fever and uroporphyrins in urine). 13190438
Glick L. Fatal agranulocytosis during treatment with amodiaquine. Br Med J 1957; 1: 932. (53 year old woman with photosensitive rash given amodiaquine for 8 weeks developed fatal agranulocytosis and jaundice; on autopsy, the liver was enlarged and had a nutmeg appearance). 13413258
Pomeroy H, Warren C, Mills D, Clark GM. The effect of amodiaquin (Camoquin) on the course of rheumatoid arthritis. Arthritis Rheum 1959; 2: 396-402. (Placebo controlled crossover study of amodiaquine in 7 elderly patients with rheumatoid arthritis; mentions in discussion that 2 of 32 patients receiving amodiaquine at their institution developed jaundice after 4 and 16 weeks of therapy, one dying of liver failure). 14433954
Bepler CR, Baier HN, McCracken S, Rentschler CL, Rogers FB, Lansbury J. A 15-month controlled study of the effects of amodiaquin (Camoquin) in rheumatoid arthritis. Arthritis Rheum 1959; 2: 403-13. (Placebo controlled crossover study of amodiaquine in 14 patients with rheumatoid arthritis; 400 mg dose was not tolerated; long term 50 mg daily doses led to jaundice in 2, Alk P elevations in 2 and AST in 4 [peak levels 100 U/L]). 13799077
Perry HO, Bartholomew LG, Hanlon DG. Nearly fatal reaction to amodiaquine. JAMA 1962; 179: 598-601. (33 year old man with systemic lupus developed fever and fatigue after 6 days of intermittent amodiaquine with rash and neutropenia [bilirubin 2.3 mg/dL, AST 101 U/L], had a rapid response to corticosteroid therapy; neutropenia lasted 2 weeks). 14485571
Cripps DJ, Curtis AC. Toxic effect of chloroquine on porphyria hepatica. Arch Dermatol 1962; 86: 575. Not in PubMed (3 patients with porphyria had exacerbation of disease after 3-4 days of chloroquine with fever, tachycardia, increase in Alk P, an increase in porphyrin excretion, and rapid improvement on stopping).
Sweeney GD, Saunders SJ, Dowdle EB, Eales L. Effects of chloroquine on patients with cutaneous porphyria of the “symptomatic” type. Br Med J 1965; 1: 1281-5. (Administration of chloroquine to 9 patients with porphyria led to fever and AST elevations [as high as 2000 U/L] and mild increases in serum bilirubin in association with increased porphyrin excretion). 14278818
Felsher BF, Redeker AG. Effect of chloroquine on hepatic uroporphyrin metabolism in patients with porphyria cutanea tarda. Medicine (Baltimore) 1966; 45: 575-83. (In patients with porphyria cutanea tarda, chloroquine caused a 3.5- to 28-fold increase in uroporphyrin excretion, usually accompanied by fever and ALT elevations [48-69 U/L] with centrolobular necrosis on liver biopsy, thereafter, patients were refractory to the side effects and treatment often induced a clinical remission). 5925910
Di Maio VJ, Henry LD. Chloroquine poisoning. South Med J 1974; 67: 1031-5. (Analysis of 27 cases of fatal overdose of chloroquine from the files of the Armed Forces Institute of Pathology: 13 suicidal, 9 accidental and 1 homicidal; 6 in children ages 1-4 years, rapid onset of vomiting, respiratory difficulties and convulsions; largely cardiotoxic). 4851012
Thornsvard CT, Guider BA, Kimball DB. An unusual reaction to chloroquine-primaquine. JAMA 1976; 235: 1719-20. (39 year old woman developed fever abdominal pain, myalgias and red urine 2 days after starting chloroquine-primaquine prophylaxis [bilirubin 0.8 mg/dL, AST >300 U/L, Alk P 60 U/L], porphyrin testing indicated porphyria cutanea tarda). 946467
Dibella NJ, Nuss DD, Aeling JL, Andrezotti RJ. Treatment of severe psoriasis with pyrimethamine. Arch Dermatol 1977; 113: 172-4. (Open label study of pyrimethamine in 7 patients with psoriasis; one patient with alcoholic cirrhosis developed AST of 371 U/L after 7 days without change in bilirubin or Alk P; liver biopsy showed fat in this patient, but biopsies in other patients on therapy were normal). 836694
Gillespie P, Wagner F. Amodiaquine agranulocytosis. Med J Aust 1977; 1: 298-9. (26 year old woman on amodiaquine prophylaxis developed skin abscess, septicemia and white count of 300/µL with no neutrophils; liver tests were “consistent with hepatocellular damage”, but no specifics given). 859490
Katz B, Weetch M, Chopra S. Quinine-induced granulomatous hepatitis. Br Med J 1983; 286: 264-5. (65 year old woman developed episodic fever, nausea and polyarthralgias after 5 months of intermittent quinine use for leg cramps [bilirubin 0.5 mg/dL, ALT 460 U/L, Alk P 375 U/L], biopsy showing granulomas; rechallenge was followed by fever and ALT rise to 480 U/L). 6402064
Nirodi NS. Quinine induced granulomatous hepatitis. Br Med J (Clin Res Ed) 1983; 286: 647. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6402190) (Letter questioning the presence of granulomas in case of Katz et al. [1983]).
Cainelli T, Di Padova C, Marchesi L, Gori G, Rovagnati P, Podenzani SA, Bessone E, et al. Hydroxychloroquine versus phlebotomy in the treatment of porphyria cutanea tarda. Br J Dermatol 1983; 108: 593-600. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%206849826) (Controlled trial of hydroxychloroquine vs twice-monthly phlebotomy in 61 patients with porphyria cutanea tarda; porphyrin excretion greater with hydroxychloroquine, but worsening liver histology found in both groups).
Gibb W, Isenberg DA, Snaith MC. Mepacrine induced hepatitis. Ann Rheum Dis 1985; 44: 861-2. (37 year old woman with systemic lupus developed jaundice 6 weeks after starting mepacrine [bilirubin 0.3 mg/dL, ALT 210 U/L, Alk P 160 U/L], resolving within 2 months of stopping). 4083944
Hatton CS, Peto TE, Bunch C, Pasvol G, Russell SJ, Singer CR, Edwards G, et al. Frequency of severe neutropenia associated with amodiaquine prophylaxis against malaria. Lancet 1986; 1: 411-4. (7 cases of severe neutropenia [0-400/µL] after 3-13 weeks of amodiaquine, lasting 3-20 days, all with recovery; some patients were jaundiced, but no specifics given). 2868340
Hirschel B. Amodiaquine and hepatitis. Ann Intern Med 1986; 105: 467. (Mentions that there have been 20 cases of agranulocytosis [12 with hepatitis] in Switzerland among travelers taking amodiaquine, and describes two patients who acquired malaria despite this prophylaxis). 3740693
Woodtli W, Vonmoos P, Siegrist P, Zollikofer H. [Amodiaquine-induced hepatitis with leukopenia]. Schweiz Med Wochenschr 1986; 116: 966-8. German. (Two cases; 40 and 55 year old travelers with fever and dark urine arising 4 and 8 weeks after starting amodiaquine [bilirubin 0.8 and 6 mg/dL, ALT 320 and 50 U/L, Alk P 171 and 186 U/L], resolving within 1-2 months of stopping, positive rechallenge in both). 3764379
Larrey D, Castot A, Pëssayre D, Merigot P, Machayekhy JP, Feldmann G, Lenoir A, et al. Amodiaquine-induced hepatitis. A report of seven cases. Ann Intern Med 1986; 104: 801-3. (Report of 7 cases of liver injury due to amodiaquine prophylaxis: 6 men and 1 woman, ages 34-64 years, taking 200-800 mg/week for 4-15 weeks, no eosinophilia or rash; 4 anicteric cases with fatigue and abdominal pain [ALT 3-6.5 times ULN, Alk P 0.6-2.7 times ULN], rapid resolution in all; 3 jaundiced cases [bilirubin 17.5-39.7 mg/dL, ALT 11-77 times ULN, Alk P 1.5-4.5 times ULN], slow resolution and minor ALT or GGT elevations persisted for more than a year). 2871789
Desaint B, Conrad M, Florent C, Legendre C, Levy VG. [Is amodiaquine(Flavoquine) hepatotoxic?]. Gastroenterol Clin Biol 1986; 10: 440. (Two cases of amodiaquine hepatotoxicity; 41 year old woman developed fatigue and jaundice 3 weeks after starting therapy [bilirubin 24.6 mg/dL, ALT 1700 U/L, Alk P 300 U/L], resolving within two months of stopping; 35 year woman old developed fatigue and abdominal pain [ALT 600 U/L] 3 months after starting amodiaquine and jaundice at 5 months [bilirubin 14.3 mg/dL, ALT 150 U/L, Alk P 213 U/L], and ascites, requiring 4 months to resolve). 3732752
Amouretti M, Raymond JM, Baldit C, Dumas F, Couzigou P, Béraud C. [Amodiaquine (Flavoquine) is hepatotoxic]. Gastroenterol Clin Biol 1986; 10: 855. French. (38 year old woman developed fatigue followed by jaundice 5 weeks after switching from chloroquine to amodiaquine [bilirubin 8.8 mg/dL, ALT 1136 U/L], with subsequent hepatic failure and death, autopsy showed massive hepatic necrosis). 3803831
Neftel KA, Woodtly W, Schmid M, Frick PG, Fehr J. Amodiaquine-induced agranulocytosis and liver damage. Br Med J 1986; 292: 721-3. (Seven cases of agranulocytosis [5 with liver involvement] and 2 of liver damage alone, seen between 1981-83; agranulocytosis arose 38-69 days after starting amodiaquine for malaria prophylaxis, persisting for 8-45 days, all with infectious complications, leading to death in 2 patients; 2 with liver damage alone were a 55 year old man and 35 year old woman who developed jaundice 42 and 120 days after starting amodiaquine [bilirubin 2.9 and 48.5 mg/dL, ALT 142 and 651 U/L, Alk P 126 and 166 U/L], one fatal). 3082410
Charmot G, Goujon C. [Minor hepatitis probably caused by amodiaquine]. Bull Soc Pathol Exot Filiales 1987; 80: 266-70. (8 patients, ages 21 to 56 years; 4 men and 4 women, found to have asymptomatic ALT elevations [86-577 U/L] without jaundice 25-300 days after starting amodiaquine, resolving within 1 week). 3608009
Stürchler D, Schär M, Gyr N. Leucopenia and abnormal liver function in travelers on malaria chemoprophylaxis. J Trop Med Hyg 1987; 90: 239-43. (Analysis of 451 travelers from Switzerland on malarial prophylaxis found higher ALT levels in those on amodiaquine than on chloroquine or no prophylaxis). 3669125
Bernuau J, Larrey D, Campillo B, Degott C, Verdier F, Rueff B, Pessayre D, et al. Amodiaquine-induced fulminant hepatitis. J Hepatol 1988; 6: 109-12. (2 men and 1 woman, ages 12, 41 and 51 years, developed jaundice 4-10 months after starting amodiaquine prophylaxis [bilirubin 30.9, 31.6 and 10.5 mg/dL, ALT 13-47 times ULN, Alk P 1.8-2.2 times ULN], all dying of hepatic failure or requiring liver transplant; liver histology showed massive necrosis). 3346531
Fogh S, Schapira A, Bygbjerg IC, Jepsen S, Mordhorst CH, Kuijlen K, Ravn P, et al. Malaria chemoprophylaxis in travellers to east Africa: a comparative prospective study of chloroquine plus proguanil with chloroquine plus sulfadoxine-pyrimethamine. Br Med J (Clin Res Ed) 1988; 296: 820-2. (Controlled trial of chloroquine with proguanil vs sulfadoxine-pyrimethamine is 767 travelers to Africa; similar efficacy and side effects; no mention of hepatic adverse events). 3130927
Raymond JM, Dumas F, Baldit C, Couzigou P, Beraud C, Amouretti M. Fatal acute hepatitis due to amodiaquine. J Clin Gastroenterol 1989; 11: 602-3. (38 year old woman developed fatigue, dark urine and then jaundice 5 weeks after switching from chloroquine to amodiaquine [bilirubin 8.8 mg/dL, ALT 1,136 U/L] with rapid improvement on stopping, but relapse 1 week after restarting [bilirubin 21.8 mg/dL, ALT 1010 U/L, Alk P 313 U/L] and progressive hepatic failure and death; autopsy showed massive necrosis). 2794450
Reisinger EC, Horstmann RD, Dietrich M. Tolerance of mefloquine alone and in combination with sulfadoxine-pyrimethamine in the prophylaxis of malaria. Trans R Soc Trop Med Hyg 1989; 83: 474-7. (Controlled trial of mefloquine alone versus mefloquine and sulfadoxine/pyrimethamine in 175 travelers; ALT or AST became abnormal in 18%, peak ALT 122 U/L with similar rates in both groups; all resolving spontaneously). 2694482
Phillips-Howard PA, West LJ. Serious adverse drug reactions to pyrimethamine-sulphadoxine, pyrimethamine-dapsone and to amodiaquine in Britain. J R Soc Med 1990; 83: 82-5. (Analysis of postmarketing adverse event reports on antimalarial drugs from UK sources; major problems were Stevens Johnson syndrome and agranulocytosis; serious hepatotoxicity occurred in 1:111,000 pyrimethamine-sulphadoxine, 1:75,200 pyrimethamine-dapsone and 1:15,500 amodiaquine users; far fewer with chloroquine-proguanil). 2138674
Mathur S, Dooley J, Scheuer PJ. Quinine induced granulomatous hepatitis and vasculitis. BMJ 1990; 300: 613. (67 year old man with fever, rash and polyarthralgias after 2 months of intermittent quinine therapy for leg cramps [bilirubin 0.6 mg/dL, AST 100 U/L, Alk P 1668 U/L], granulomas on liver biopsy and rapid recovery upon stopping). 2108777
Punukollu RC, Kumar S, Mullen KD. Quinine hepatotoxicity: an under recognized or rare phenomenon? Arch Intern Med 1990; 150: 1112-3. (37 year old woman developed fever, headache, arthralgias and abdominal pain without rash 2-3 weeks after starting quinine for leg cramps [bilirubin 1.8 mg/dL, ALT 128 U/L, Alk P 327 U/L, eosinophils 6%], rapid improvement with stopping quinine, normal in 1 week; positive rechallenge to one dose with fever and ALT to 64 U/L). 2331190
Clarke JB, Neftel K, Kitteringham NR, Park BK. Detection of antidrug IgG antibodies in patients with adverse drug reactions to amodiaquine. Int Arch Allergy Appl Immunol 1991; 95: 369-75. (Amodiaquine antibodies found in 6 of 7 patients with adverse reactions and 7 of 22 without while on amodiaquine prophylaxis; reactivity not blocked by other aminoquinones). 1959977
Lobel HO, Miani M, Eng T, Bernard KW, Hightower AW, Campbell CC. Long-term malaria prophylaxis with weekly mefloquine. Lancet 1993; 341: 848-51. (Study on 421 Peace Corps volunteers in West Africa on different antimalarial regimens including mefloquine, chloroquine and proguanil; no serious adverse events; ALT levels not monitored; mefloquine decreased P. falciparum infection rate). 8096560
Steffen R, Fuchs E, Schildknecht J, Naef U, Funk M, Schlagenhauf P, Phillips-Howard P, et al. Mefloquine compared with other malaria chemoprophylactic regimens in tourists visiting east Africa. Lancet 1993; 341: 1299-303. (In flight questionnaires of returning travelers from East Africa between 1985 and 1991; side effects reported by 17-35%, higher with combinations; 4 deaths, evidently from malaria). 8098447
Boudreau E, Schuster B, Sanchez J, Novakowski W, Johnson R, Redmond D, Hanson R, et al. Tolerability of prophylactic malaria regimens. Trop Med Parasitol 1993; 44: 257-65. (Controlled trial of mefloquine vs chloroquine in 359 US Marines for 12 weeks; no differences in ALT levels between groups; mefloquine caused mild psychological side effects and insomnia). 8256107
Palmer KJ, Holliday SM, Brogden RN. Mefloquine. A review of its antimalarial activity, pharmacokinetic properties and therapeutic efficacy. Drugs 1993; 45: 430-75. (Review on mefloquine which is used as prophylaxis and treatment of chloroquine-resistant P. falciparum malaria; transient increases of ALT have been observed with prophylactic and therapeutic regimens; 4 cases of hepatitis have been reported to the manufacturer). 7682911
Makin AJ, Wendon J, Fitt S, Portmann BC, Williams R. Fulminant hepatic failure secondary to hydroxychloroquine. Gut 1994; 35: 569-70. (Two cases; 27 year old woman developed nausea after 2 weeks of hydroxychloroquine [bilirubin 9.4 mg/dL, ALT 2575 U/L, INR 3.3], with subsequent liver failure and death in 4 days; 16 year old woman developed jaundice after 2 weeks of therapy with hydroxychloroquine [bilirubin 24.4 mg/dL, AST 544 U/L] and renal failure; underwent liver transplant, but died 6 days later). 8175002
Perez JA, Stryker J, Arsura EL, Hewitt JM. Probable quinine-induced hepatotoxicity. West J Med 1994; 160: 59-60. (74 year old developed fever, abdominal pain and jaundice one month after starting quinine for leg cramps [bilirubin 7.2 mg/dL, ALT 241 U/L, Alk P 314 U/L, ESR 65], biopsy showing granulomas and rapid resolution upon stopping). 8128710
Man-Song-Hing M, Wells G. Meta-analysis of efficacy of quinine for treatment of nocturnal leg cramps in elderly people. BMJ 1995; 10: 13-7. (Meta analysis of 107 patients from 6 clinical trials of quinine for leg cramps; quinine reduced number of nights without leg cramps by 27%; no discussion of hepatotoxicity). 7827545
Liu AC. Hepatotoxic reaction to chloroquine phosphate in a patient with previously unrecognized porphyria cutanea tarda. West J Med 1995; 162: 548-51. (61 year old woman developed nausea and fever 1 day after single dose of chloroquine with red urine [bilirubin 1.1 mg/dL, ALT 2724 U/L, Alk P 115 U/L], later diagnosed as having porphyria cutanea tarda). 7618323
Jaspers CAJJ, Hoperus Buma APCC, Van Thiel PPAM, Van Hulst RA, Kager PA. Tolerance of mefloquine chemoprophylaxis in Dutch military personnel. Am J Trop Med Hyg 1996; 55: 230-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%208780466) (Study of 73 volunteers on mefloquine for 25 weeks; slight increase in mean ALT levels, but no value rose above normal).
Barrett PJ, Emmins PD, Clarke PD, Bradley DJ. Comparison of adverse events associated with the use of mefloquine and combination of chloroquine and proguanil as antimalarial prophylaxis: a postal and telephone survey of travelers. BMJ 1996; 313: 525-8. (Mail questionnaire of 3851 British travelers taking mefloquine or chloroquine/proguanil for malaria prophylaxis; rates of side effects were similar [~41%], no mention of hepatic events). 8789977
Horney E, Lagerstedt C, Wadenvik H. [A case report. Thrombocytopenia and granulomatous hepatitis caused by quinine]. Lakartidningen 1996; 93: 361-4. Swedish. (58 year old man developed intermittent fevers while on quinine [bilirubin normal, ALT 185 U/L, GGT 145 U/L, thrombocytopenia], with recovery on stopping and recurrence on rechallenge). 8628066
Hou M, Horney E, Stockelberg D, Jacobsson S, Kutti J, Wadenvik H. Multiple quinine-dependent antibodies in a patient with episodic thrombocytopenia, neutropenia, lymphocytopenia, and granulomatous hepatitis. Blood 1997; 90: 4806-11. (58 year old man with recurrent, transient bouts of fever, nausea, thrombocytopenia and ALT elevations [4-6 times ULN] shown to be due to intermittent exposure to quinine, with positive rechallenge and demonstration of quinine dependent antibodies to platelets and white blood cells). 9389697
Ribeiro IR, Olliaro P. Safety of artemisinin and its derivatives. A review of published and unpublished clinical trials. Med Trop (Mars) 1998; 58 (Suppl 3): 50-3. (Systematic review of 108 studies of artemisinin derivatives enrolling 9241 patients found low rate of adverse events, with elevated ALT levels in only 36 patients [0.9%] and no severe adverse events that could be attributed to the drug). 10212898
Durrheim DN, Gammon S, Waner S, Braacke LE. Antimalarial prophylaxis: use and adverse events in visitors to the Kruger National Park. S Afr Med J 1999; 89: 170-5. (Postal survey of 7397 visitors to Kruger Park in 1996, a chloroquine-resistant area; no mention of hepatic adverse events). 10191871
Grieco A, Vecchio FM, Natale L, Gasbarrini G. Acute fatty liver after malaria prophylaxis with mefloquine. Lancet 1999; 353: 295-6. (46 year old woman developed nausea, weight loss and edema and was found to have enlarged and fatty liver several months after a 5 week course of mefloquine prophylaxis against malaria [ALT 41 U/L, Alk P 161 U/L, no bilirubin values given], resolving over next month; relationship to amodiaquine therapy unclear). 9929030
Farver DK, Lavin MN. Quinine-induced hepatotoxicity. Ann Pharmacother 1999: 33: 32-4. (57 year old developed fever, nausea and myalgias within 24 hours of starting quinine for leg cramps [temperature 39.5 oC, ALT 184 U/L, Alk P 192 U/L, bilirubin 0.7 mg/dL], resolving in 3 weeks). 9972382
Gotsman I, Azaz-Livshits T, Fridlender Z, Muszkat M, Ben-Chetrit E. Mefloquine-induced acute hepatitis. Pharmacotherapy 2000; 20: 1517-9. (68 year old man developed fatigue and nausea after 6 weeks of mefloquine prophylaxis [bilirubin 1.9 mg/dL, ALT 1277 U/L, LDH 7770 U/L, Alk P normal, INR 7.4], but also had atrial flutter and heart failure, rapid recovery; overall, more typical of ischemic hepatitis than drug induced liver injury). 11130224
van Jaarsveld CHM, Jahangier ZN, Jacobs JWG, Blaauw AAM, van Albada-Kuipers GA, ter Borg EJ, Brus HLM, et al. Toxicity of antirheumatic drugs in a randomized clinical trial of early rheumatoid arthritis. Rheumatology 2000; 39: 1374-82. (Controlled trial of 4 treatment strategies in 419 patients with early rheumatoid arthritis; side effects were common with ALT elevations in 5 patients on NSAIDs only, 1 each on gold and hydroxychloroquine, and 20 on methotrexate). 11136881
Høgh B, Clarke PD, Camus D, Nothdurft HD, Overbosch D, Günther M, Joubert I, et al.; Malarone International Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in non-immune travelers: a randomised, double-blind study. Malarone International Study Team. Lancet 2000; 356: 1888-94. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 1008 travelers; efficacy was similar, but gastrointestinal upset was more common with chloroquine [20% vs 12%]; among 180 with laboratory testing “No clinically important laboratory abnormalities were identified”). 11130385
Overbosch D, Schilthuis H, Bienzle U, Behrens RH, Kain KC, Clarke PD, Toovey S, et al. Malarone International Study Team. Atovaquone-proguanil versus mefloquine for malaria prophylaxis in nonimmune travelers: results from a randomized, double-blind study. Clin Infect Dis 2001; 33: 1015-21. (Controlled trial of atovaquone-proguanil vs mefloquine of malaria prophylaxis in 483 travelers; similar efficacy [100%] but neuropsychiatric side effects were more common with mefloquine [29% vs 14%] including insomnia, anxiety, vivid dreams, dizziness and trouble concentrating; no mention of liver injury and ALT levels were not monitored). 11528574
Orrell C, Taylor WR, Olliaro P. Acute asymptomatic hepatitis in a healthy normal volunteer exposed to 2 oral doses of amodiaquine and artesunate. Trans R Soc Trop Med Hyg 2001; 95: 517-8. (In a single dose crossover study in 15 volunteers, one developed rise in ALT from normal to peak of 483 U/L 6 weeks after dosing with amodiaquine and artesunate without symptoms or bilirubin rise, resolving in 4-8 weeks). 11706664
Sarkany RP. The management of porphyria cutanea tarda. Clin Exp Dermatol 2001; 26: 225-32. (History, clinical features, pathogenesis, risk factors, complications and management of porphyria cutanea tarda; caused by acquired inhibition of hepatic uroprophyrinogen decarboxylase activity and triggered by iron overload, estrogens, or chemicals such as hexachlorobenzene; “Low dose twice weekly chloroquine [125-250 mg] is the mainstay of therapy”). 11422163
Croft AM, Herxheimer A. Adverse effects of the antimalaria drug, mefloquine: due to primary liver damage with secondary thyroid involvement? BMC Public Health 2002; 2: 6. (Systematic review of 516 published case reports of adverse effects of mefloquine suggests that many such as malaise, fever, anorexia, headache, abdominal pain and nausea are due to “transient, anicteric chemical hepatitis,” although abnormal liver tests are found in only a proportion). 11914150
Croft AM, Whitehouse DP, Cook GC, Beer MD. Safety evaluation of the drugs available to prevent malaria. Expert Opin Drug Saf 2002; 1: 19-27. (Review of adverse side effects of antimalarial agents, pointing out the need for careful prospective randomized controlled trials of prophylactic regimens). 12904156
Angles A, Bagheri H, Montastruc JL, Magnaval JF; Réseau Français des Centres Régionaux de Pharmacovigilance. [Adverse drug reactions (ADRs) to antimalarial drugs. Analysis of spontaneous report from the French pharmacovigilance database (1996-2000)]. Presse Med 2003; 32: 106-13. French. (Analysis of adverse reactions to antimalarials reported in France over 5 years; among 508 reports, 4% were hepatic, mostly ALT elevations; one case of hepatitis attributed to halofantrine). 12610379
Hirschel B. Questions about the antimalarial amodiaquine. Lancet 2003; 361: 1229; author reply 1229-30. (Questions the advisability of using amodiaquine because of the risk of severe granulocytopenia; authors reply that the crisis of malaria and chloroquine resistance in Africa warrants use of amodiaquine for treatment, estimated fatality rate being 1:31,000 and severe hepatotoxicity as 1:15,650). 12686075
Howard MA, Hibbard AB, Terrell DR, Medina PJ, Vesely SK, George JN. Quinine allergy causing acute severe systemic illness: report of 4 patients manifesting multiple hematologic, renal, and hepatic abnormalities. Proc (Bayl Univ Med Cent) 2003; 16: 21-6. (Four case reports of quinine induced thrombocytopenia with other systemic manifestations, including prominent AST [131, 992, 741 and 3735 U/L] and mild Alk P [74-170 U/L] elevations and 2 with jaundice [bilirubin 4.3 and 16.1 mg/dL]; often inadvertent quinine use from over-the-counter pills). 16278718
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none were attributed to an antimalarial agent). 15390328
Schlegel A. Factitious granulomatous hepatitis? Am J Med 2004; 116: 500-1. (35 year old woman with relapsing episodes of fever, abdominal pain and ALT elevations [1488 U/L] and biopsy showing small granulomas, finally confessed to intermittent, purposeful use of quinine). 15047046
Camus D, Djossou F, Schilthuis HJ, Høgh B, Dutoit E, Malvy D, Roskell NS, et al.; International Malarone Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in nonimmune pediatric travelers: results of an international, randomized, open-label study. Clin Infect Dis 2004; 38: 1716-23. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 221 children; efficacy was similar [100%], but side effects slightly more frequent with chloroquine [mostly gastrointestinal]; no mention of liver injury or ALT elevations). 15227617
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of the toxicities and side effects of antimalarials; quinine can cause a characteristic hypersensitivity reaction with liver injury; chloroquine can cause worsening of acute porphyria; sulfadoxine/pyrimethamine is associated with clinically apparent liver injury similar to that of sulfonamides; mefloquine can cause transient ALT elevations and rarely hepatitis; atovaquone/proguanil can cause minor ALT elevations; quinine can cause a characteristic hypersensitivity reaction with liver injury; amodiaquine is linked to agranulocytosis and hepatitis in 1:2000 recipients; artemisinin derivatives are associated with ALT elevations in 0.9% and has been linked to rare cases of severe hepatitis; primaquine can cause hemolysis, but has not been linked to cases of hepatitis). 14720085
Grieshaber M, Lämmli J, Marcus L. Acute hepatitis and atovaquone/proguanil. J Travel Med 2005; 12: 289-90. (31 year old man developed jaundice and abdominal pain 25 days after starting atovaquone/proguanil prophylaxis [bilirubin 2.9 mg/dL, ALT 320 U/L, Alk P 445 U/L], resolving slowly within 7 weeks of stopping). 16256055
Patel SN, Kain KC. Atovaquone/proguanil for the prophylaxis and treatment of malaria. Expert Rev Anti Infect Ther 2005; 3: 849-61. (Review of chemistry, clinical results and safety of atovaquone/proguanil concludes that it is well tolerated; hepatotoxicity and ALT elevations were not discussed). 16307498
Wielgo-Polanin R, Lagarce L, Gautron E, Diquet B, Lainé-Cessac P. Hepatotoxicity associated with the use of a fixed combination of chloroquine and proguanil. Int J Antimicrob Agents 2005; 26: 176-8. (50 year old woman developed jaundice 4 days after starting chloroquine/proguanil for prophylaxis of malaria [bilirubin 3.6 mg/dL, ALT 600 U/L, Alk P 744 U/L], resolving within one month of stopping; had a history of previous exposures to both agents). 16009537
Sowunmi A, Fehintola FA, Adedeji AA, Gbotosho GO, Tambo E, Fateye BA, Happi TC, Oduola AM. Open randomized study of artesunate-amodiaquine vs. chloroquine-pyrimethamine-sulfadoxine for the treatment of uncomplicated Plasmodium falciparum malaria in Nigerian children. Trop Med Int Health 2005; 10: 1161-70. (Controlled trial of 3 day regimens of artesunate-amodiaquine vs chloroquine-pyrimethamine-sulfadoxine in 153 children with malaria; “biochemical … parameters remained normal before and after treatment in all subjects”). 16262741
Fanello CI, Karema C, van Doren W, Rwagacondo CE, D'Alessandro U. Tolerability of amodiaquine and sulphadoxine-pyrimethamine, alone or in combination for the treatment of uncomplicated Plasmodium falciparum malaria in Rwandan adults. Trop Med Int Health 2006; 11: 589-96. (Controlled trial of amodiaquine vs sulfadoxine/pyrimethamine vs both in 351 patients with malaria in Rwanda; ALT levels decreased during therapy, but no mention of hepatotoxicity or hepatitis). 16640610
Rossmann-Ringdahl I, Olsson R. Porphyria cutanea tarda: effects and risk factors for hepatotoxicity from high-dose chloroquine treatment. Acta Derm Venereol 2007; 87: 401-5. (Retrospective analysis of 57 patients with porphyria cutanea tarda treated with chloroquine [250 mg/day for 7 days]; ALT rose in all averaging 7 times ULN [range 1.1 to 55 times] with symptoms of fever and arthralgias and increase in porphyrin excretion, higher levels in women; ALT flare was followed by remission, but relapse was common during long term follow up). 17721646
Markham LN, Giostra E, Hadengue A, Rossier M, Rebsamen M, Desmeules J. Emergency liver transplantation in amodiaquine-induced fulminant hepatitis. Am J Trop Med Hyg 2007; 77: 14-5. (39 year old woman developed fatigue and then jaundice ~10 weeks after starting amodiaquine prophylaxis for malaria [bilirubin 14 mg/dL, ALT 1475 U/L, Alk P 108 U/L, protime 17%]; underwent successful liver transplant 6 days later, liver showed massive necrosis). 17620624
Bruguera M, Herrera S. [Acute hepatitis associated with mefloquine therapy]. Gastroenterol Hepatol 2007; 30: 102-3. Spanish. (35 year old woman physician developed nausea and pruritus followed by jaundice 2 months after starting mefloquine prophylaxis [bilirubin 7.1 mg/dL, ALT 2411 U/L, Alk P 614 U/L], resolving 5 weeks after stopping: Case 1 in mefloquine). 17335720
Zongo I, Dorsey G, Rouamba N, Tinto H, Dokomajilar C, Guiguemde RT, Rosenthal PJ, Ouedraogo JB. Artemether-lumefantrine versus amodiaquine plus sulfadoxine-pyrimethamine for uncomplicated falciparum malaria in Burkina Faso: a randomised non-inferiority trial. Lancet 2007; 369 (9560): 491-8. (Controlled trial of artemether-lumefantrine vs sulfadoxine-pyrimethamine and amodiaquine in 521 patients with malaria; adverse event rates were similar and no mention of ALT levels or hepatotoxicity). 17292769
Osorio L, Gonzalez I, Olliaro P, Taylor WR. Artemisinin-based combination therapy for uncomplicated Plasmodium falciparum malaria in Colombia. Malar J 2007; 6: 25. (Controlled trial of 3 day courses of amodiaquine alone vs its combination with artemisinin in 85 patients with P. falciparum malaria; equivalence efficacy and safety; ALT elevations in 4% overall, but without clinical symptoms). 17328806
Giner Galvañ V, Oltra MR, Rueda D, Esteban MJ, Redón J. Severe acute hepatitis related to hydroxychloroquine in a woman with mixed connective tissue disease. Clin Rheumatol 2007; 26: 971-2. (26 year old woman with early rheumatoid arthritis developed fever and nausea within 10 hours of starting hydroxychloroquine with ALT 285 U/L [no bilirubin or Alk P levels] and rapid resolution; yet, no recurrence on restarting at a lower dose). 16575495
Efferth T, Romero MR, Wolf DG, Stamminger T, Marin JJ, Marschall M. The antiviral activities of artemisinin and artesunate. Clin Infect Dis 2008; 47: 804-11. (Review of in vitro data on antiviral activity of the artemisinins derived from sweet wormwood). 18699744
Gasasira AF, Kamya MR, Achan J, Mebrahtu T, Kalyango JN, Ruel T, Charlebois E, et al. High risk of neutropenia in HIV-infected children following treatment with artesunate plus amodiaquine for uncomplicated malaria in Uganda. Clin Infect Dis 2008; 46: 985-91. (Analysis of safety of artesunate and amodiaquine in children with malaria; ALT elevations occur in less than 1% of recipients). 18444813
Maiteki-Sebuguzi C, Jagannathan P, Yau VM, Clark TD, Njama-Meya D, Nzarubara B, Talisuna AO, et al. Safety and tolerability of combination antimalarial therapies for uncomplicated falciparum malaria in Ugandan children. Malar 2008; 7: 106. (Controlled trial of 3 combination regimens in 382 children with malaria in Uganda; ALT elevations occurred in 0.5% with amodiaquine/artesunate, 0.3% with amodiaquine/sulfadoxine/pyrimethamine, 0.6% with artemether-lumefantrine). 18547415
Adjei GO, Kurtzhals JA, Rodrigues OP, Alifrangis M, Hoegberg LC, Kitcher ED, Badoe EV, et al. Amodiaquine-artesunate vs artemether-lumefantrine for uncomplicated malaria in Ghanaian children: a randomized efficacy and safety trial with one year follow-up. Malar 2008; 7: 127. (Controlled trial of artesunate-amodiaquine vs artemether-lumefantrine in 227 children with malaria in Ghana; similar efficacy; ALT levels improved during therapy and no reports of hepatitis or ALT increases). 18620577
Leslie T, Mayan I, Mohammed N, Erasmus P, Kolaczinski J, Whitty CJ, Rowland M. A randomised trial of an eight-week, once weekly primaquine regimen to prevent relapse of plasmodium vivax in Northwest Frontier Province, Pakistan. PLoS One 2008; 3: e2861. (Among 200 patients with vivax malaria infection randomized to receive two regimens of primaquine in addition to chloroquine therapy for vivax malaria infection, primaquine reduced failure rates and there were "no serious or notable non-serious adverse events", except for anemia in one G6PD deficient patient). 18682739
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was attributed to artesunate [adjudicated as only "possible"], but no other antimalarial agent was listed). 18955056
Sirima SB, Tiono AB, Gansané A, Diarra A, Ouédraogo A, Konaté AT, Kiechel JR, et al. The efficacy and safety of a new fixed-dose combination of amodiaquine and artesunate in young African children with acute uncomplicated Plasmodium falciparum. Malar J 2009; 8: 48. (Controlled trial of fixed vs “loose” dose combinations of amodiaquine and artesunate in 750 children with P. falciparum malaria; similar efficacy [92%] and safety; 7 [~1%] had ALT elevations, one >1000 U/L, but bilirubin normal and no symptoms). 19291301
Guévart E, Aguémon A. [Two cases of fulminant hepatitis during a curative treatment with an artesunate-amodiaquine combination]. Med Mal Infect 2009; 39: 57-60. French. (Two cases of acute liver failure; 32 year old African woman given artesunate and amodiaquine for fever developed fatigue and anemia 3 days later with ALT 483 U/L and progressive hepatic failure; 44 year old African physician treated for fever with artesunate and amodiaquine developed fatigue after 3 and jaundice after 5 days, with ALT 15,000 U/L and progressive hepatic failure). 19013042
Ndiaye JL, Randrianarivelojosia M, Sagara I, Brasseur P, Ndiaye I, Faye B, Randrianasolo L, et al. Randomized, multicentre assessment of the efficacy and safety of ASAQ--a fixed-dose artesunate-amodiaquine combination therapy in the treatment of uncomplicated Plasmodium falciparum malaria. Malar J 2009; 8: 125. (Controlled trial of artesunate-amodiaquine vs artemether-lumefantine for 3 days in 940 patients with malaria; response rates and side effects were similar in the two groups; rates of ALT elevations decreased during therapy and follow up, from 9% to 6%). 19505304
Kayentao K, Maiga H, Newman RD, McMorrow ML, Hoppe A, Yattara O, Traore H, Kone Y, et al. Artemisinin-based combinations versus amodiaquine plus sulphadoxine-pyrimethamine for the treatment of uncomplicated malaria in Faladje, Mali. Malar J 2009; 8: 5. (Controlled trial of 3 day courses of 3 different antimalarial regimens in 397 children with malaria; no difference in side effects, but regimens with sulfadoxine-pyrimethamine had superior response rates). 19128455
Sinclair D, Zani B, Donegan S, Olliaro P, Garner P. Artemisinin-based combination therapy for treating uncomplicated malaria. Cochrane Database Syst Rev 2009; (3): CD007483. (Review of 50 trials of artemisinin based regimens, as therapy of malaria does not mention or discuss hepatotoxicity or ALT elevations). 19588433
Centers for Disease Control and Prevention(CDC). Hepatitis temporally associated with an herbal supplement containing artemisinin – Washington, 2008. MMWR Morb Mortal Wkly Rep 2009; 58: 854-6. (Artemisinin is available in several over-the-counter herbal products; 52 year old man developed jaundice after 7 days of taking herbal product with high concentrations of artemisinin [~600 mg per day] [bilirubin 3.1 mg/dL, ALT 898 U/L, Alk P 258 U/L], resolving with within 2 weeks: Case 1 for artemisinin). 19680221
Mali S, Steele S, Slutsker L, Arguin PM; Centers for Disease Control and Prevention (CDC). Malaria surveillance – United States, 2008. MMWR Surveill Summ 2010; 59: 1-15. (In 2008, there were 1298 reports of malaria in persons living in the US and 2 deaths; almost all cases were associated with travel to endemic areas, with highest risk from Western Africa). 20577158
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to antimalarials). 20648003
Ayede IA, Falade AG, Sowunmi A, Jansen FH. An open randomized clinical trial in comparing two artesunate-based combination treatments on Plasmodium falciparum malaria in Nigerian children: artesunate/sulphamethoxypyrazine/pyrimethamine (fixed dose over 24 hours) versus artesunate/amodiaquine (fixed dose over 48 hours). Malar J 2010; 9: 378. (Among 250 children with malaria treated with artesunate either with sulfamethoxypyrazine and pyrimethamine over 24 hours or with amodiaquine over 48 hours, there were no hepatic serious adverse events and mean ALT and AST levels did not change). 21194422
Ebringer A, Heathcote G, Baker J, Waller M, Shanks GD, Edstein MD. Evaluation of the safety and tolerability of a short higher-dose primaquine regimen for presumptive anti-relapse therapy in healthy subjects. Trans R Soc Trop Med Hyg 2011; 105: 568-73. (Among 203 Australian soldiers treated with primaquine as a higher dose 7 day regimen, there were no "clinically significant differences ... in biochemical indices before and after treatment"). 21890160
Bojang K, Akor F, Bittaye O, Conway D, Bottomley C, Milligan P, Greenwood B. A randomised trial to compare the safety, tolerability and efficacy of three drug combinations for intermittent preventive treatment in children. PLoS One 2010; 5 (6): e11225. (Controlled trial comparing 3 regimens for prevention of endemic malaria in 1008 Gambian children, 331 of whom received amodiaquine once monthly for 2-3 months; no severe adverse reactions were detected and no mention of liver injury, hepatitis or jaundice). 20574538
Tine RC, Faye B, Sylla K, Ndiaye JL, Ndiaye M, Sow D, Lo AC, et al. Efficacy and tolerability of a new formulation of artesunate-mefloquine for the treatment of uncomplicated malaria in adult in Senegal: open randomized trial. Malar J 2012; 11: 416. (310 Senegalese patients with malaria were treated with artesunate and mefloquine vs artesunate and lumefantrine for 3 days; both regimens were highly effective and well tolerated, mean serum ALT levels did not change and no serious adverse events were reported). 23234606
Rueangweerayut R, Phyo AP, Uthaisin C, Poravuth Y, Binh TQ, Tinto H, Pénali LK, et al; Pyronaridine–Artesunate Study Team. Pyronaridine-artesunate versus mefloquine plus artesunate for malaria. N Engl J Med 2012; 366: 1298-309. (Among 1271 patients in Asia and Africa treated for malaria with an artesunate combination regimen for 3 days, ALT elevations occurred in none of 423 mefloquine treated, but in 2.5% [21 of 848] of pyronaridine-artesunate treated subjects including 15 with ALT above 5 times ULN and 2 patients with jaundice, but with symptomatic hepatitis). 22475593
Brasseur P, Vaillant MT, Olliaro PL. Anti-malarial drug safety information obtained through routine monitoring in a rural district of South-Western Senegal. Malar J 2012; 11: 402. (Analysis of safety information obtained through routine monitoring of of ~3,000 cases of acute malaria treated with various regimens [usually with artemisinin] in a rural district in Senegal, found no significant changes in laboratory tests except for a decrease in ALT and AST from pretreatment values, and no deaths or severe adverse event attributable to liver injury). 23216982
Zwang J, Dorsey G, Djimdé A, Karema C, Mårtensson A, Ndiaye JL, Sirima SB, et al. Clinical tolerability of artesunate-amodiaquine versus comparator treatments for uncomplicated falciparum malaria: an individual-patient analysis of eight randomized controlled trials in sub-Saharan Africa. Malar J 2012; 11: 260. (Among 3113 patients treated with artesunate and amodiaquine for falciparum malaria in 8 controlled trials, common treatment-emergent side effects were cough [33%], anorexia [17%], vomiting [15%], diarrhea [17%], pruritus [18%] and weakness [16%]; 4 patients [1%] developed jaundice, but no details provided). 22856598
Thanh NX, Trung TN, Phong NC, Quang HH, Dai B, Shanks GD, Chavchich M, et al. The efficacy and tolerability of artemisinin-piperaquine (Artequick®) versus artesunate-amodiaquine (Coarsucam™) for the treatment of uncomplicated plasmodium falciparum malaria in south-central Vietnam. Malar J 2012; 11: 217. (Controlled trial comparing aremisinin with either piperaquine [n=63] for 2 days or with amodiaquine [65] for 3 days for falciparum malaria in Vietnam reported similar efficacy and tolerance; no severe adverse events reported and no mention of liver injury, jaundice or ALT elevations). 22741618
Askling HH, Bruneel F, Burchard G, Castelli F, Chiodini PL, Grobusch MP, Lopez-Vélez R, Paul M, et al.; European Society for Clinical Microbiology and Infectious Diseases Study Group on Clinical Parasitology. Management of imported malaria in Europe. Malar J 2012;11: 328. (Recommendations on treatment of malaria from a European panel; atovaquone-proguanil is a first line treatment for uncomplicated P. falciparum malaria; ALT elevations and hepatotoxicity are not mentioned). 22985344
Kimura M, Koga M, Kikuchi T, Miura T, Maruyama H. Efficacy and safety of atovaquone-proguanil in treating imported malaria in Japan: the second report from the research group. Parasitol Int 2012; 61: 466-9. (30 cases of P. falciparum or vivax malaria in Japan were treated successfully with atovaquone-proguanil; one patient with P. falciparum had abnormal liver tests [bilirubin 2.0 mg/dL, ALT 294 U/L], with thrombocytopenia [48,000/μL] that resolved within 4 weeks of treatment). 22484597
Advice for travelers. Treat Guidel Med Lett 2012; 10 (118): 45-56. (Concise guidelines on prevention of malaria in travelers indicates that atovaquone-proguanil is an effective prophylaxis against choloroquine resistant Plasmodium species, "...generally the best tolerated prophylactic, but it can cause headhache, insomnia, GI disturbances and mouth ulcers, and is expensive. Single case reports of Stevens Johnson syndrome and hepatitis have been published.") 22777212
John GK, Douglas NM, von Seidlein L, Nosten F, Baird JK, White NJ, Price RN. Primaquine radical cure of Plasmodium vivax: a critical review of the literature. Malar J 2012; 11: 280. (Review of the activity, efficacy and safey of primaquine as therapy and means of prevention of relapse of vivax malaria). 22900786
Baird KJ, Maguire JD, Price RN. Diagnosis and treatment of Plasmodium vivax malaria. Adv Parasitol 2012; 80: 203-70. (Extensive review of the history and modern approach to diagnosis and treatment of vivax malaria; primaquine has been shown to be effective in preventing relapse and might play a role in the reaching of a goal of elimination of malaria transmission; side effects are few and usually minor except in persons with G6PD deficiency, a problem for the developing world). 23199489
Sutanto I, Tjahjono B, Basri H, Taylor WR, Putri FA, Meilia RA, Setiabudy R, et al. Randomized, open-label trial of primaquine against vivax malaria relapse in Indonesia. Antimicrob Agents Chemother 2013; 57: 1128-35. (Prospective trial of three regimens for vivax malaria among 116 Indonesian soliders; primaquine was 92-98% effective in preventing relapse and "most laboratory findings" including serum ALT and alkaline phosphatase levels remained normal before, during and after treatment). 23254437
Schramm B, Valeh P, Baudin E, Mazinda CS, Smith R, Pinoges L, Sundaygar T, et al. Tolerability and safety of artesunate-amodiaquine and artemether-lumefantrine fixed dose combinations for the treatment of uncomplicated Plasmodium falciparum malaria: two open-label, randomized trials in Nimba County, Liberia. Malar J 2013; 12: 250. (Analysis of safety from two prospective controlled trials conducted in Liberia comparing 3 day courses of artesunate-amodiaquine to artemether-lumefantrine in treating uncomplicated Plasmodium falciparum malaria; ALT elevations occurred in 2.0-5.2% of patients and "the only clinical hepatotoxicity was mild jaundice in one patients"). 23866736
Cordel H, Cailhol J, Matheron S, Bloch M, Godineau N, Consigny PH, Gros H, et al. Atovaquone-proguanil in the treatment of imported uncomplicated Plasmodium falciparum malaria: a prospective observational study of 553 cases. Malar J 2013; 12: 399. (Among 553 French travelers treated for uncomplicated malaria with atovaquone-proguanil, parasitemia cleared in all patients by day 7 and only 3 patients relapsed; side effects included nausea or vomiting [17%], headache [7%], and rash [2%]. "As observed in the literature, this study did not reveal any liver toxicity"). 24200190
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an antimalarial agent). 23419359
Yeka A, Lameyre V, Afizi K, Fredrick M, Lukwago R, Kamya MR, Talisuna AO. Efficacy and safety of fixed-dose artesunate-amodiaquine vs. artemether-lumefantrine for repeated treatment of uncomplicated malaria in Ugandan children. PLoS One 2014; 9: e113311. (Among 413 Ugandan children with repeated [n=6027] episodes of malaria treated each time with one of two artemisinin combination regimens, cure and adverse event rates were similar and liver tests abnormalities occurred in 6.5% overall and were treatment related in 0.5%, but all resolved spontaneously and there were no instances of clinically apparent liver injury). 25436614
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antimalarial agent). 24552865
Advice for travelers. Treat Guidel Med Lett 2015: 57 (1466): 52-8. (Concise guidelines on prevention of malaria in travelers). 25853663
Yeka A, Kigozi R, Conrad MD, Lugemwa M, Okui P, Katureebe C, Belay K, et al. Artesunate/amodiaquine versus artemether/lumefantrine for the treatment of uncomplicated malaria in Uganda: a randomized trial. J Infect Dis 2016; 213: 1134-42. (Among 602 Ugandan children with malaria treated with artesunate-amodiaquine or artemether-lumefantrine, adverse event rates were similar with the 2 regimens and there were no serious hepatic adverse events; no mention of ALT elevations). 26597254
Coulibaly B, Pritsch M, Bountogo M, Meissner PE, Nebié E, Klose C, Kieser M, et al. Efficacy and safety of triple combination therapy with artesunate-amodiaquine-methylene blue for falciparum malaria in children: a randomized controlled trial in Burkina Faso. J Infect Dis 2015; 211: 689-97. (Among 221 children with falciparum malaria treated with artesunate-amodiaquine with or without methylene blue for 3 days, serious adverse events were uncommon and none were liver related; no mention of ALT elevations or hepatotoxicity). 25267980
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to an antimalarial drug, but one occurred in a patient taking an herbal supplement that reportedly contained artemisinin). 25754159
Twomey PS, Smith BL, McDermott C, Novitt-Moreno A, McCarthy W, Kachur SP, Arguin PM. Intravenous artesunate for the treatment of severe and complicated malaria in the United States: clinical use under an investigational new drug protocol. Ann Intern Med 2015; 163: 498-506. (Among 102 US patients with severe malaria treated with intravenous artesunate, the mortality rate was 7% but all deaths were considered due to malaria; ALT or AST elevations occurred in 51%, but most were mild-to-moderate in severity and self-limited in course; there were no instances of clinically apparent liver injury attributed to antimalarial therapy). 26301474
Kumar S. Cholestatic liver injury secondary to artemisinin. Hepatology 2015; 62: 973-4. (43 year old woman developed jaundice 6 weeks after starting an herbal supplement containing artemisinin [bilirubin 15.4 mg/dL, ALT 675 U/L, Alk P 208 U/L, INR 1.1], resolving slowly upon withdrawal, jaundice lasting 4 months). 25980398
Adjei A, Narh-Bana S, Amu A, Kukula V, Nagai RA, Owusu-Agyei S, Oduro A, et al. Treatment outcomes in a safety observational study of dihydroartemisinin/piperaquine (Eurartesim(®)) in the treatment of uncomplicated malaria at public health facilities in four African countries. Malar J 2016; 15: 43. (Among 1002 patients with malaria treated in 4 African countries with dihydroartemisinin with piperaquine who were tested for ALT and AST, mean levels decreased during therapy and there was no "significant liver or renal impairment", but ALT levels were still elevated at day 7 in 11.5% and serum bilirubin in 7.6% of patients). 26818128
Silva-Pinto A, Ruas R, Almeida F, Duro R, Silva A, Abreu C, Sarmento A. Artemether-lumefantrine and liver enzyme abnormalities in non-severe Plasmodium falciparum malaria in returned travellers: a retrospective comparative study with quinine-doxycycline in a Portuguese centre. Malar J 2017; 16: 43. (Among 57 travellers treated for non-severe malaria, 10 [18%] developed liver enzyme elevations, more commonly with artemether-lumefantrine [42%] than quinine-doxycycline [5%], but none developed clinically apparent liver injury). 28122572
http://www.cdc.gov/MALARIA/. (CDC website with information on malaria, its prevention and treatment including current guidelines which are updated regularly).

## OTHER REFERENCE LINKS

1. Recent References on Antimalarials: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(antimalarial+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Antimalarials: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=antimalarial)